# Prasugrel

## OVERVIEW

### Introduction

Prasugrel is an inhibitor of platelet aggregation that is used to decrease the risk of myocardial infarction and stroke in patients with acute coronary syndromes. Prasugrel has been linked to mild and transient serum enzyme elevations during therapy and to rare instances of hypersensitivity reactions accompanied by mild liver injury.

### Background

Prasugrel (pra' soo grel) is a thienopyridine inhibitor of adenosine diphosphate (ADP) receptors (P2Y12) on platelets, and is used as an anticoagulant to decrease the risk of recurrent coronary thromboses in patients who undergo interventions during an acute coronary syndrome. Activated platelets release ADP which binds to ADP platelet receptors, causing activation of the intracellular glycoprotein IIb/IIIA complex which triggers platelet adherence and aggregation. The aggregation of platelets plays an important role in the growth of atheromatous plaques, which can lead to coronary, cerebral and peripheral arterial occlusions. Prasugrel is an irreversible inhibitor of the P2Y12 receptor and its effects last for the life time of the platelet (7 to 10 days). In clinical trials, prasugrel therapy during acute coronary events (unstable angina and myocardial infarction) was equivalent or slightly better than clopidogrel in decreasing the frequency of recurrence of myocardial infarction and stent thrombosis. Prasugrel was approved for use in the United States in 2009. Current indications are reduction of recurrent cardiovascular events in patients with acute coronary syndromes who are to be managed with percutaneous coronary intervention. Prasugrel is available in 5 and 10 mg tablets generically and under the commercial name Effient. The usual oral dose is a loading dose of 60 mg followed by 10 mg daily in combination with aspirin. The most common side effect is bleeding (usually epistaxis); other side effects are not common, but can include headache, dizziness, fatigue, gastrointestinal upset, nausea, arthralgias and rash. Rare, but more severe adverse events include major episodes of bleeding and hypersensitivity reactions including anaphylaxis.

### Hepatotoxicity

Prasugrel is associated with low rates of serum enzyme elevations during therapy, which are similar to those with clopidogrel. In premarketing studies, no instances of clinically apparent liver injury were reported. Since marketing and release, there has been several reports of liver injury attributed to prasugrel often as a part of a hypersensitivity reaction. The onset was within a few weeks of switching from clopidogrel to prasugrel, and was accompanied by mild-to-moderate ALT and GGT elevations that resolved rapidly once prasugrel was replaced by clopidogrel. The liver injury was overshadowed by features of a hypersensitivity syndrome with fever, eosinophilia and diarrhea, which also reversed rapidly with stopping prasugrel. Autoantibodies were not reported. There has also been one report of a case of hepatocellular jaundice that resolved only after stopping prasugrel. There have been no reports of chronic injury or acute liver failure reported with prasugrel, although such instances have been reported with clopidogrel and ticlopidine.

Likelihood score: D (possible rate cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of prasugrel hepatotoxicity is not known, but is likely to be immunologically mediated and due to hypersensitivity. Prasugrel requires metabolic activation for its antiplatelet effects, which occurs in the liver primarily via the cytochrome P450 system, CYP 3A4 and 2B6. Inhibitors of CYP 3A4 (such as clarithromycin or itraconazole) may result in higher levels of prasugrel and antiplatelet activity, whereas inducers of CYP 3A4 (such as rifampin or phenytoin) may lower levels and result in less of an antiplatelet response.

### Outcome and Management

The severity of liver injury associated with prasugrel has been mild and rapidly reversible with stopping therapy. In one instance, switching anticoagulant therapy to clopidogrel was tolerated without recurrence. Rechallenge should be avoided.

Drug Class: Antithrombotic Agents, Antiplatelet Agents

Other Drugs in the Subclass, Antiplatelet Agents: Aspirin, Cangrelor, Clopidogrel, Dipyridamole, Ticagrelor, Ticlopidine, Vorapaxar

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Prasugrel – Generic, Effient®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Prasugrel)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Prasugrel | 150322-43-3 | C20-H20-F-N-O3-S

## ANNOTATED BIBLIOGRAPHY

References updated: 15 September 2020

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999; ticlopidine, but not clopidogrel or prasugrel is discussed).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 528. (Review of hepatotoxicity of antiplatelet drugs mentions that prasugrel is a recently approved inhibitor of platelet aggregation and has yet to be linked to cases of clinically apparent liver injury).
Hogg K, Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 849-76. (Textbook of pharmacology and therapeutics).
Wiviott SD, Braunwald E, McCabe CH, Montalescot G, Ruzyllo W, Gottlieb S, Neumann FJ, et al., TRITON-TIMI 38 Investigators. (2007). Prasugrel versus clopidogrel in patients with acute coronary syndromes. N Engl J Med. (Controlled trial comparing prasugrel to clopidogrel in 13,608 patients with acute coronary syndromes with planned intervention found similar rates of efficacy, but higher rates of major bleeding with prasugrel [2.4% vs 1.8%]; no mention of ALT elevations or hepatotoxicity).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to antiplatelet agents).
Scott DM, Norwood RM, Parra D. (2009). P2Y12 inhibitors in cardiovascular disease: focus on prasugrel. Ann Pharmacother. (Review of efficacy and safety of prasugrel in comparison to other antiplatelet agents; mentions that: "..elevated liver function tests could occur with prasugrel treatment").
(2009). Prasugrel (Effient) vs. clopidogrel (Plavix). Med Lett Drugs Ther. (Concise review of pharmacology, efficacy and safety of prasugrel in relation to clopidogrel, mentions the main adverse events is bleeding which is more common with prasugrel; no mention of hepatotoxicity or ALT elevations).
Mohammad RA, Goldberg T, Dorsch MP, Cheng JW. (2010). Antiplatelet therapy after placement of a drug-eluting stent: a review of efficacy and safety studies. Clin Ther. (Systematic review of studies of antiplatelet therapy after coronary stenting discussed bleeding complications only, no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to antiplatelet medications).
(2011). Antithrombotic drugs. Treat Guidel Med Lett. (Guidelines on the use of antiplatelet drugs, including aspirin, clopidogrel, prasugrel, ticagrelor and ticlopidine, mentions that prasugrel appears to be more effective than clopidogrel, but has a greater risk of bleeding; no mention of hepatotoxicity or ALT elevations).
Roe MT, Armstrong PW, Fox KA, White HD, Prabhakaran D, Goodman SG, Cornel JH, et al., TRILOGY ACS Investigators. (2012). Prasugrel versus clopidogrel for acute coronary syndromes without revascularization. N Engl J Med. (Among 7243 patients with unstable angina or myocardial infarction treated with prasugrel or clopidogrel for up to 30 months, both efficacy and safety were similar between the two groups; no mention of ALT elevations or hepatotoxicity).
Fernández-Ruiz M, Carbonell-Porras A, García-Reyne A, López-Medrano F. (2012). Management of a hypersensitivity reaction to thienopyridines: prasugrel-induced fever and hepatitis resolved after switching to clopidogrel. Rev Esp Cardiol. (40 year old woman developed fever, eosinophilia, diarrhea and liver enzyme elevations starting a few weeks after switching from clopidogrel to prasugrel [peak ALT 155 U/L, GGT 723 U/L, 10% eosinophils], resolving rapidly upon switching back).
Serebruany VL, Kipshidze N, Pershukov IV, Kuliczkowski W, Carnes J, Atar D. (2014). Fatal sepsis and systemic inflammatory response syndrome after off-label prasugrel: a case report. Am J Ther. (65 year old man developed hypersensitivity reaction with high fever, confusion and rash 6 days after switching from clopidogrel to prasugrel, with subsequent multiorgan failure and death from sepsis by 16 days; few details given).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to prasugrel).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to prasugrel: a 49 year old man who developed jaundice 3 months after starting prasugrel, atorvastatin and ranolazine that did not improve after stopping atorvastatin and ranolazine, but did after stopping prasugrel 6 weeks later).
Schüpke S, Neumann FJ, Menichelli M, Mayer K, Bernlochner I, Wöhrle J. (2019). Richardt Get al.; ISAR-REACT 5 Trial Investigators. Ticagrelor or Prasugrel in Patients with Acute Coronary Syndromes. N Engl J Med. (Among 4018 patients with acute coronary syndromes treated with ticagrelor or prasugrel for one year, major cardiovascular events were less with prasugrel [6.9% vs 9.3%], but major bleeding event rates were similar [4.8% vs 5.4%]; no mention of ALT elevations or hepatotoxicity).
Nakamura M, Kitazono T, Kozuma K, Sekine T, Nakamura S, Shiosakai K, Iizuka T. (2019). Prasugrel for Japanese patients with ischemic heart disease in long-term clinical practice (PRASFIT-Practice II)- 1-year follow-up results of a postmarketing observational study. Circ J. (Among 4155 Japanese patients followed in a postmarketing observation study after starting prasugrel, major bleeding episodes occurred in 1%, any bleeding episode in 5.5% and 0.2% developed abnormal liver tests; no details provide).
Navarese EP, Khan SU, Kołodziejczak M, Kubica J, Buccheri S, Cannon CP, Gurbel PA, et al. (2020). Comparative efficacy and safety of oral P2Y12 inhibitors in acute coronary syndrome: network meta-analysis of 52 816 from 12 randomized trials. Circulation. (Metaanalysis of 12 randomized controlled trials in 52,816 patients comparing 3 antiplatelet agents found that prasugrel and ticagrelor had lower rates of cardiovascular mortality and stent thrombosis than clopidogrel, but had higher rates of major bleeding episodes; no mention of ALT elevations or hepatotoxicity).
Tarantini G, Mojoli M, Varbella F, Caporale R, Rigattieri S, Andò G, Cirillo P, et al.; DUBIUS Investigators, on behalf of the Italian Society of Interventional Cardiology (SICI-GISE). Timing of oral P2Y inhibitor administration in non-ST elevation acute coronary syndrome. J Am Coll Cardiol 2020: S0735-1097(20)36444-5. Epub ahead of print. (Among 1449 patients undergoing coronary angiography treated with prasugrel or ticagrelor, rates of a combined clinical efficacy endpoint were similar in the two groups; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Prasugrel: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Prasugrel/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Prasugrel: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Prasugrel)